# Kava Kava

## OVERVIEW

### Introduction

Kava kava is an herbal derived from roots of the plant Piper methysticum, which has been used for centuries as a recreational and ceremonial drink in Oceania and more recently in concentrated forms in herbal medications to treat anxiety and insomnia. Products labeled as kava have been linked to the development of clinically apparent acute liver injury which can be severe and even fatal.

### Background

Kava kava is an herbal derived from roots of the plant Piper methysticum (“intoxicating Pepper” plant), a member of the pepper family found in the Western and South Pacific. More commonly referred to simply as “kava” (bitter), it has been used for centuries as a recreational and ceremonial drink in Oceania (Polynesia, Micronesia and Macronesia). It is prepared from the roots of the plant which are ground into a fine pulp to which water is added. The active ingredients are kavapyrones (kavalactones), which have effects similar to alcohol, such as relaxation, talkativeness, and euphoria, while reportedly maintaining mental clarity. For these reasons, kava has been proposed to be anxiolytic and used in patients with anxiety disorders and as treatment for insomnia, premenstrual syndrome and stress. Kava appears to have an abuse potential, but it is rare with conventional doses. Recently, concerns have arisen regarding the safety of kava products, in particular due to reports of liver injury. For this reason, the use of kava has been banned or restricted in many countries of the world such as Germany, Switzerland, France, Canada, and Great Britain. However, several groups have disputed the evidence for hepatotoxicity, suggesting that responsibility for liver injury lies with adulterants or concomitant drugs or herbals. Furthermore, the literature on liver injury from kava has included several incomplete or overlapping reports, and causality was rarely well shown. Nevertheless, there are a small number of cases of severe hepatic injury arising during therapy that are convincing. Kava in many formulations remains available from nutrition stores and the Internet.

The kava pyrones are believed to have anxiolytic, analgesic, muscle relaxing, and anticonvulsant effects, mediated by effects on the limbic system, the part of the brain linked to emotions. The mechanism of action of the pharmacological effects of kava has yet to be elucidated. Research has demonstrated that several factors, including concentration, type of preparation, kava pyrone content, and kava variety used may affect pharmacologic activity. Therapeutic uses of kava include the treatment of anxiety, insomnia, and stress. Its abuse potential is low, but not absent. Suggested dosage for treatment of nonpsychotic anxiety is 105 to 210 mg daily for three to four weeks. The most common side effects of kava are headache, dizziness, drowsiness, depression, diarrhea, and occasionally dermatologic manifestations.

### Hepatotoxicity

The frequency of adverse reactions to kava, particularly liver injury, is not known. Based upon reported cases, the estimated frequency of clinically apparent liver injury due to kava is less than 1:1,000,000 daily doses. However, spontaneous reporting is believed to capture less than 1% of severe adverse events from the use of dietary supplements. Between 50 and 100 cases of clinically apparent liver injury have been published or discussed in the literature. Advocates of the herbal have strongly rejected these numbers, disputing both their accuracy and the causality assessment process. Still, there seem to be convincing evidence in some cases of severe hepatitis ending in fulminant hepatic failure, requiring liver transplantation, and even leading to death. Patients typically present with fatigue, nausea, elevations in serum aminotransferase levels, and jaundice 2 to 24 weeks after starting use of the product. The pattern of enzyme elevations is hepatocellular with marked elevations in serum aminotransferase and minimal increases in alkaline phosphatase levels. In some cases, features of immunoallergic hepatitis (rash, fever, eosinophilia, and recurrence on reexposure) are present. Liver biopsy findings include focal hepatocellular necrosis, lobular inflammation and intrahepatic cholestasis. In more severe cases there is massive or submassive necrosis.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatotoxicity from kava is unclear. In vitro studies suggest that the kavalactones are not intrinsically cytotoxic, although other components of kava preparations may be. Kava can also cause herb-drug interaction. Although in vitro studies suggest that kavalactones inhibit several cytochrome P450 isoenzymes, human studies suggest that it is a inhibitor of CYP 2E1 alone, and that its effects are modest. Clinical cases of hepatotoxicity due to kava suggest an idiosyncratic or immunoallergic pathogenesis. The possibility of mislabeling or adulteration with hepatotoxic herbals is always an issue.

### Outcome and Management

The severity of liver injury ranges from transient and moderate enzyme elevations to symptomatic acute hepatitis to acute liver failure. In most instances, the liver injury subsides within 1 to 3 months of discontinuing the herbal product, but if fulminant hepatitis develops, a liver transplant may be required. Rechallenge leads to prompt recurrence and should be avoided.

Other Names: Intoxicating pepper, kavain, kawa pepper

Drug Class: Herbal and Dietary Supplements

## CASE REPORTS

### Case 1. Acute liver failure treated with liver transplantation after kava use.

[Modified from: Brauer RB, Stangl M, Stewart JR, Pfab R, Becker K. Acute liver failure after administration of herbal tranquilizer kava-kava (Piper methysticum). J Clin Psychiatry 2003; 64: 216-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/12633134)]

A 22 year old woman presented with a 3 week history of nausea and fatigue, followed by jaundice 4 months after starting kava kava (240 mg daily). Her other medications included oral contraceptives (norgestimate, 180-250 μg and ethinyl estradiol, 35 μg) for a year and a half, and rizatriptan (10 mg) and acetaminophen (500 mg) approximately twice a month as needed for migraine headaches. She was initially found to be jaundiced with a serum bilirubin of 10.4 mg/dL. She was told to stop kava. A week later she was hospitalized for worsening jaundice and mental slowing. At that point, serum bilirubin was 40 mg/dL, ALT 2442 U/L, alkaline phosphatase 246 U/L, and the prothrombin time index <20% (Table). Tests for hepatitis A, B and C were negative. Autoantibodies were not detected and immunoglobulin levels were normal. Ultrasonography showed no gall stones and no evidence of biliary obstruction. Despite supportive care, she developed progressive hepatic encephalopathy and was placed on the liver transplant waiting list. Three days later a donor organ became available, and liver transplantation was performed. The explanted liver was small (780 g) and histology showed massive necrosis with few residual hepatocytes. Her posttransplant course was complicated by recurrent cytomegalovirus infections and prolonged jaundice, but she gradually improved and was discharged 12 weeks after transplantation. Six months after transplant she developed disseminated aspergillosis which led to her death from multiorgan failure.

#### Key Points

Medication: | Kava kava (240 mg of kavalactone daily)
Pattern: | Hepatocellular (R=71)
Severity: | 5+ (liver transplantation, death)
Latency: | 16 weeks
Recovery: | None
Other medications: | Norgestimate, ethinyl estradiol, rizatriptan, acetaminophen

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
| | Started kava (240 mg kavapyrone daily)
16 weeks | 0 | 519 | | 10.4 | Nausea and jaundice,
17 weeks | 1 week | 2442 | 246 | 40.0 | Grade I encephalopathy
| 1.5 weeks | 453 | 287 | 28.5 | Comatose grade II - IV
| | Liver transplant performed
7 months | 14 weeks | 115 | | 12.9 | Discharge
Normal Values | | <17 | <130 | <1.2

#### Comment

This patient developed a severe acute hepatitis-like syndrome 4 months after starting kava kava for depression. Other causes of acute liver injury were appropriately excluded. Progressive hepatic failure followed and led to emergency liver transplantation. Because at least a dozen instances of acute liver failure have been reported in patients taking kava, the agent has been banned in many countries as an over-the-counter product for therapy of anxiety or mood disorders. The argument that prescription anxiolytic agents have a similar rate of severe hepatic reactions is not correct. Prescription medications with the number of published instances of severe hepatic injury attributed to kava would be similarly withdrawn from use.

### Case 2. Death from acute liver failure after kava kava use.

[Modified from: Gow PJ, Connelly NJ, Hill RL, Crowley P, Angus PW. Fatal fulminant hepatic failure induced by a natural therapy containing kava. Med J Aust 2003; 178: 442-3. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/12720510)]

In July 2002, a 56 year old Australian woman who had been taking a kava product for three months developed nausea and jaundice. The product was provided by a naturopath for anxiety to be taken three times daily: Kava 1800 Plus was labeled as containing 60 mg of kavalactones, 50 mg of Passiflora incarnata (maypop, passion flower) and 100 mg of Scutellaria laterifloria (blue skullcap). She had no previous major medical problems except for benign monoclonal gammopathy. She had initially been seen with a two week history of fatigue, nausea and increasing jaundice. She had no risk factors for viral hepatitis, no history of liver disease and drank minimal amounts of alcohol. She had also been taking some vitamin and mineral supplements, but no other prescription medications. Examination upon hospital admission revealed deep jaundice, but no fever, rash or signs of chronic liver disease. Laboratory tests showed a total bilirubin of 12.2 mg/dL, ALT 4539 U/L, alkaline phosphatase 190 U/L, albumin 3.4 g/dL and INR 2.3 (Table). Tests for acute hepatitis A, B, and C were negative as were serology of acute Epstein Barr virus and cytomegalovirus infection. Serum copper and ceruloplasmin levels were normal. Antinuclear antibodies were present in a titer of 1:160, without smooth muscle antibodies and with stable serum immunoglobulin levels. Plasma acetaminophen levels were negative. An abdominal ultrasound revealed a small liver with normal flow in the hepatic arteries, hepatic veins and portal veins and no evidence of extrahepatic obstruction. A trans-jugular liver biopsy showed severe acute hepatitis with marked parenchymal necrosis and collapse. Over the next week, she developed deepening jaundice, coagulopathy and hepatic encephalopathy and was listed for transplantation which was performed on hospital day 17. The surgery was complicated by massive bleeding that did not correct following implantation of the donor liver, and the patient died of circulatory failure. Histological examination of the explanted liver confirmed the presence of massive hepatic necrosis.

#### Key Points

Medication: | Kava
Pattern: | Hepatocellular (R=55)
Severity: | 5+ (liver transplantation, death)
Latency: | 3 months (jaundice)
Recovery: | None
Other medications: | Passiflora incarnata, Scutellaria laterifloria, vitamins and minerals

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | Pre | Started Kava 1800 Plus (180 mg kavalactones daily)
12 weeks | 0 | 4539 | 190 | 12.2 | INR=2.3
14 weeks | 17 days | 438 | 357 | 35.5 | INR=6.6
14 weeks | 17 days | Liver transplantation: death from surgical complications
Normal Values | | <55 | <130 | <1.2

#### Comment

This patient developed a severe acute hepatitis-like syndrome, followed by acute liver failure three months after starting a kava containing combination herbal medication. Other causes of acute liver injury were excluded. This case occurred after a warning was made by the Australian Regulatory agency and stresses the difficulty of managing risks that are very rare, but nevertheless potentially profound. While the herbal medication that she was taking included multiple components, the association of hepatic injury with kava has been far stronger than with the other listed herbals. The possibility of mislabeling or contamination of the herbal preparation was raised with the case, but these concerns affect all herbals that are not formally regulated.

### Case 3. Acute hepatitis attributed to kava.

[Modified from: Bujanda L, Palacios A, Silvarino R, Sanchez A, Munoz C. [Kava-induced acute icteric hepatitis], Gastroenterol Hepatol 2002; 25: 434-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/12069710)]

A 55 year old man using kava extract (250 mg capsule, 3 times daily) for 2 weeks began to experience weakness, fatigue and right upper quadrant discomfort. He continued taking the extract for 3 months when he developed jaundice. He denied taking any other medications and denied alcohol use or risk factors for viral hepatitis. Liver tests were known to have been normal in the past. On physical examination, he was jaundiced but had no signs of chronic liver disease, rash or fever. Laboratory tests showed a total serum bilirubin of 6.5 mg/dL, ALT 2300 U/L, AST 1506 U/L, alkaline phosphatase 514 U/L and GGT 874 U/L (Table). The prothrombin index was 60%. Tests for hepatitis A, B and C were negative as were routine autoantibodies. Abdominal ultrasound and magnetic resonance cholangiography showed no evidence of extrahepatic obstruction. A liver biopsy showed centrilobular hemorrhagic necrosis without steatosis, fibrosis, or cholestasis and with minimal mixed inflammatory infiltrates. Two weeks after stopping the kava product, liver tests began to improve and were near normal when he was seen four months later.

#### Key Points

Medication: | Kava
Pattern: | Hepatocellular (R=12.8)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 2 weeks (fatigue, weakness), 3 months (jaundice)
Recovery: | 4 months
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
| Started kava (250 mg three times daily)
3 months | 0 | 2300 | 514 | 6.5 | Kava stopped
4 months | 1 month | 1018 | 613 | 8.6
5 months | 2 months | 200 | 454 | 3.8
6 months | 3 months | 35 | 178 | 1.4
Normal Values | | 40 | 130 | <1.2

#### Comment

The hepatocellular pattern of serum enzyme elevations with jaundice arising within 3 months of starting kava without other explanations is strong evidence supporting a diagnosis of kava induced hepatic injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Kava Kava – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/kava)

Fact Sheet at Office of Dietary Supplements, NIH (https://ods.od.nih.gov/Health_Information/kava.aspx)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Kava Kava | 9000-38-8 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2018

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications linked to liver injury are discussed, but not kava).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbals including kava mentions that more than 100 cases of liver injury have been attributed to kava products, used for their relaxing and anxiolytic properties).
Mathews JD, Riley MD, Fejo L, Munoz E, Munos E, Milns NR, Gardner ID, et al. Effects of the heavy usage of kava on physical health: Summary of a pilot survey in an aboriginal community. Med J Aust 1988; 148: 548-55. (Survey of health of kava users among Aboriginal community in Australia found GGT levels 4 to 6 fold higher in heavy kava users compared to non-users; ALT levels not tested). 3374423
Singh YN. Kava: an overview. J Ethnopharmacol 1992; 37: 13-45. (Historical review of kava and its uses in Oceania; initially used for ceremonial purposes, kava has come to occupy a central place in everyday life and has become a drug of abuse in some populations; because of its relaxing and socializing effects, kava has been introduced into Western countries as an anxiolytic herbal usually as an alcohol extract in pill form). 1453702
Strahl S, Ehret V, Dahm HH, Maier KP. [Necrotizing hepatitis after taking herbal remedies] Dtsch Med Wochenschr 1998; 123: 1410-4. German. (39 year old woman developed acute hepatitis after taking kavapyrone for 5 months [bilirubin 1.7 rising to 12.3 mg/dL, ALT 796 U/L, Alk P 389 U/L], resolving within 2 months of stopping and recurring soon upon restarting). 9856112
Almeida JC, Grimsely EW. Coma from the health food store: Interaction between kava and alprazolam. Ann Int Med 1996; 125: 940-1. (54 year old man developed disorientation and coma 3 days after starting kava, while also taking alprazolam and cimetidine, drug-interactions perhaps explaining the serious neurological adverse event; liver tests not reported). 8967683
Escher M, Desmeules J, Giostra E, Mentha G. Hepatitis associated with Kava, a herbal remedy for anxiety. BMJ 2001; 322: 139. Erratum in: BMJ 2001; 322: 1097. (50 year old man developed jaundice 2 months after starting kava capsules [3-4/day] [bilirubin 16.9 mg/dL, ALT 70 times ULN, Alk P 430 U/L, prothrombin index 25%], with progressive hepatic failure requiring emergency liver transplantation). 11159570
Russmann S, Lauterburg BH, Helbling A. Kava hepatotoxicity. Letter. Ann Intern Med 2001; 135: 68-9. (33 year old woman developed jaundice 3 weeks after a second use of Laitan [kavalactone] [bilirubin 23 mg/dL, ALT 2430 U/L, Alk P 299 U/L], positive lymphocyte transformation test to kavalactone, resolving in 8 weeks). 11434754
Kraft M, Spahn TW, Menzel J, Senninger N, Dietl KH, Herbst H, Domschke W, et al. [Fulminant liver failure after administration of the herbal antidepressant kava-kava]. Dtsch Med Wochenschr 2001; 126: 970-2. German. (60 year old woman developed jaundice while taking kava kava for an unknown duration [bilirubin 30 mg/dL, ALT 1350 U/L, Alk P 580 U/L, prothrombin index <10%], with progressive hepatic failure requiring liver transplantation 11 days later - 18th case of kava related acute liver failure). 11544547
Bujanda L, Palacios A, Silvarino R, Sanchez A, Munoz C. [Kava-induced acute icteric hepatitis], Gastroenterol Hepatol 2002; 25: 434-5. Spanish. (55 year old man developed jaundice 3 months after starting kava extract [bilirubin 8.6 mg/dL, ALT 2300 U/L, Alk P 514 U/L, prothrombin index 65%], with recovery 4 months after stopping: Case 3). 12069710
Wooltorton E. Herbal kava: reports of liver toxicity. CMAJ 2002; 166: 777. (Canadian health care alert after 25 cases of severe liver injury were reported from Europe, listing multiple names for kava). 11944767
De Smet PA. Safety concerns about kava not unique. Lancet 2002: 1336. (Letter indicating that celandine, like kava, has been linked to several cases of severe liver injury and a warning label added in Germany). 12414243
Ernst E. Safety concerns about kava. Lancet 2002; 359: 1865. (The European Agency for Evaluation of Medicinal Products has identified 30 cases of liver injury, including 6 cases of liver failure attributable to kava; UK retailers have removed kava from shelves). 12044412
Centers for Disease Control and Prevention. Hepatic toxicity possibly associated with kava-containing products-United States, Germany, and Switzerland, 1999-2002. JAMA 2003: 36-7. (Report of 2 cases of liver failure attributable to kava in the US; 15 and 45 year old females developing jaundice 2 and 3.5 months after starting kava, both of whom required emergency liver transplant). 12500906
BfArM (Federal Institute for Drugs and Medicinal Products in Germany) 2002. http://www.scribd.com/doc/49052596/BfArM-Public-Statement-on-Withdrawal-Kava-Kava-Assessment-Report-14-06-2002 (German warning about kava).
Center for Food Safety and Applied Nutrition (CFSAN): Kava-containing dietary supplements may be associated with severe liver injury. US Department of Health and Human Services, Food and Drug Administration, Rockville, Maryland, March 25, 2002. (http://www.cfsan.fda.gov/~dms/ds-warn.html). 2002. (Letter reporting over 25 cases of liver adverse events from kava in other countries. Advisory warning of removal of kava from the marketplace in Germany, Switzerland, France, Canada, and the UK noted. Consumers asked to report any new instances of liver injury).
Center for Food Safety and Applied Nutrition (CFSAN): Consumer advisory: kava-containing dietary supplements may be associated with severe liver injury(document issued March 25, 2002), Rockville, Maryland: US Department of Health and Human Services, Food and Drug Administration, 2002. (http://www.fda.gov/Food/ResourcesForYou/Consumers/ucm085482.htm). (Advisory about the potential risk of hepatotoxicity from kava).
Denham A, McIntyre M, Whitehouse J. Kava—the unfolding story: report on a work-in-progress. J Altern Complement Med 2002; 8: 237-63. (Article written on behalf of the Traditional Medicines Evaluation Committee protesting the decision in Germany to warn the public about kava hepatotoxicity based on 30 reported cases of liver injury from kava, claiming that evidence of causality was poor, some cases were duplications and that the concentrated extracts differ from the aqueous extracts in traditional use). 12165183
Bilia AR, Gallon S, Vincieri FF. Kava-kava and anxiety: growing knowledge about the efficacy and safety. Life Sci 2002; 70: 2581-97. (Review of the activity of kava in decreasing anxiety, relieving stress at doses that are well tolerated and not associated with addiction; the recent report of liver toxicity was unexpected and remains unexplained and possibly due to contaminants). 12269386
Parkman CA. Another FDA warning: Kava supplements. Case Manager 2002; 13: 26-8. (FDA consumer warning and short review of the efficacy and side effects of kava, encouraging reporting of adverse events to MedWatch). 12131903
Campo JV, McNabb J, Perel JM, Mazariegos GV, Hasegawa SL, Reyes J. Kava induced fulminant hepatic failure. J Am Acad Child Adolesc Psychiatry 2002; 41: 631-2. (Case reported above by FDA of 14 year old girl who developed fulminant hepatic failure requiring liver transplantation after taking a kava containing herbal for 3 months [bilirubin 16.2 mg/dL, ALT 4076, GGT 148 U/L], first report of fatal kava hepatotoxicity in a child). 12049436
Stevinson C, Huntley A, Ernst E. A systematic review of the safety of kava extract in the treatment of anxiety. Drug Safety 2002; 25: 251-61. (Systematic review of safety of kava: 9 published cases of liver damage, arising 3 weeks to 4 months after starting, often with immunoallergic features; another 24 unpublished reports made to German regulatory agency with 1 death and 3 liver transplants; conclusion that kava is well tolerated when taken short term in recommended doses; however, further research is needed). 11994028
Schmidt M. Are kavalactones the hepatotoxic principle of kava extracts? The pitfalls of the glutathione theory. J Altern Complement Med 2003; 9: 183-7. (Detailed summary of animal toxicology studies with kava showing no evidence of hepatotoxicity of kavalactones in vitro or in vivo). 12804070
Brauer RB, Stangl M, Stewart JR, Pfab R, Becker K. Acute liver failure after administration of herbal tranquilizer kava-kava (Piper methysticum). J Clin Psychiatry 2003; 64: 216-8. (22 year old woman developed nausea 4 months after starting kava [240 mg of kavapyrone daily], with bilirubin 10.5 rising to 40 mg/dL, ALT 2442 U/L, Alk P 246 U/L and subsequent progressive hepatic failure and liver transplantation: Case 1). 12633134
Schulze J, Raasch W, Ciegers CP. Toxicity of kava pyrones, drug safety and precautions – a case study. Phytomedicine 2003; 10 Suppl 4: 68-73. (Editorial questioning the appropriateness of the ban placed on kava, based upon the cases of hepatic injury reported to German and Swiss regulatory authorities, arguing that the evidence that kava was the cause of the liver injury was poor and the efficacy of kava outweighs its hepatotoxic risks). 12807347
Gow PJ, Connelly NJ, Hill RL, Crowley P, Angus PW. Fatal fulminant hepatic failure induced by a natural therapy containing kava. Med J Aust 2003; 178: 442-3. (56 year old woman developed jaundice 3 months after starting kava [bilirubin 12.2 mg/dL, ALT 4539 U/L, Alk P 190 U/L, INR 2.3], with progressive liver failure requiring liver transplantation, dying post-operatively: Case 2). 12720510
Currie BJ, Clough AR. Kava hepatotoxicity with western herbal products: Does it occur with traditional kava use? Med J Aust 2003; 178:421-2. (Editorial based on report by Gow [2003] mentioning the lack of liver injury among Aboriginal people who use kava, and linking adverse effects to the process [using alcohol and acetone] of extracting and concentrating kavalactone). 12720503
Whitton PA, Lau A, Salisbury A, Whitehouse J, Evans CS. Kava lactones and the kava-kava controversy. Phytochemistry 2003; 64: 673-9. (Analysis of extraction techniques in preparing kava; alcohol and acetone retrieve >95%, whereas water extracts ~3% of kavalactones; water extraction also retains glutathione which may help detoxify bioreactive components). 13679089
Clough AR, Jacups SP, Wang Z, Burns CB, Bailie RS, Cairney SJ, Collie A, et al. Health effects of kava use in an eastern Arnhem Land Aboriginal community. Int Med J 2003; 33: 336-40. (Cross sectional study of kava users in Northern Territory of Australia among Aboriginal Community showed a higher frequency of dermopathy, increased alkaline phosphatase and GGT levels [but not ALT] between users and non-users). 12895162
Clough AR, Bailie RS, Currie B. Liver function test abnormalities in users of aqueous kava extracts. J Toxicol Clin Toxicol 2003; 41: 821-9. (Cross sectional survey of 98 Australian aboriginal people for kava use, finding higher levels of GGT [78 vs 34 U/L] and Alk P [165 vs 109 U/L] in recent users vs non-users, but no differences in ALT [25.5 vs 24 U/L], the abnormalities being reversible and not associated with clinical symptoms). 14677792
Russmann S, Barguil Y, Cabalion P, Kritsanida M, Duhet D, Lauterburg BH. Hepatic injury due to traditional aqueous extracts of kava root in New Caledonia. Eur J Gastroenterol Hepatol 2003; 15: 1033-6. (Two cases of acute liver injury from a South Pacific Island in 55 and 59 year old women of Oceanian origin who started drinking kava regularly for 4 and 5 weeks and then presented with jaundice [bilirubin 1.8 and 12.9 mg/dL, ALT 568 and 1666 U/L], resolving in 3 months in both; a survey among 27 heavy kava users found GGT elevations in 85% and ALT elevations in 11%). 12923378
Humberston CL, Akhtar J, Krenzelok EP. Acute hepatitis induced by kava kava. J Toxicol Clin Toxicol 2003; 41: 109-13. (14 year old female developed jaundice after taking a kava containing herbal [“Tension Tamers”] for 4 months for anxiety over her parents separation [bilirubin 15.5 mg/dL, ALT >4400 U/L, GGT 127 U/L, INR 3.4], with progressive liver failure requiring emergency transplant; apparently same case as in Campo [2002], but some differences in details). 12733846
Estes JD, Stoplman D, Olyaei A, Corless CL, Ham JM, Schwartz JM, Orloff SL. High prevalence of potentially hepatotoxic supplement use in patients with fulminant hepatic failure. Arch Surg 2003; 138: 852-8. (Among 20 cases of acute liver failure referred for liver transplantation in 2001-2002, 7 were associated with herbal use including 3 patients taking kava, 2 “Lipokinetix”, 1 Ma Huang and 1 chaparral). 12912743
Mills SY, Steinhoff B. Kava-kava: a lesson for the phytomedicine community. Phytomedicine 2003; 10: 261-2. (Editorial questioning the decision to ban kava in Germany and the UK: “A remedy with established efficacy and long standing popularity has been withdrawn, with severe damage to the economies of several small Pacific nations, on the basis of uncertain reports”). 12725583
Teschke R, Gaus W, Loew D. Kava extracts: safety and risks including rare hepatotoxicity. Phytomedicine 2003; 10: 440-6. (Review of 19 cases of kava hepatotoxicity reported to regulatory groups questioning the causality and the basis of its ban; on closer scrutiny, only 1 case could be considered “probable”, 1 “possible”, 5 “unlikely” and 12 “unassessable” because of missing information). 12834011
Teschke R. [Kava, kavapyrones and toxic liver injury]. Z Gastroenterol 2003; 41: 395-404. German. (Kava extracts are recommended in daily doses of 60-120 mg of kavapyrones for up to 3 months; reports of hepatotoxicity have largely been in patients who exceeded these recommendations). 12772052
Stickel F, Baumuller H-B, Seitz K, Vasilakis D, Seitz G, Seitz HK, Schuppan D. Hepatitis induced by Kava (Piper methysticum rhizome). J Hepatol 2003; 39: 62-7. (Evaluation of 7 published and 29 unpublished [German] cases of liver injury attributed to kava between 1990 and 2002, rated 3 as “certain”, 21 as “probable” and 12 as at least “possible”; 9 had acute liver failure, 8 underwent transplant and 3 died; latency was 2 weeks to 2 years [median=4.5 months], with idiosyncratic or immunoallergic mechanisms most likely, occurring with both acetone and alcohol extracts and from multiple commercial sources). 12821045
Clouatre DL. Kava kava: examining new reports of toxicity. Toxicol Lett 2004; 150: 85-96. (Review of efficacy and safety of kava concludes that hepatotoxicity is an idiosyncratic reaction and that the “risk-to-benefit ratio of kava extracts remains good” in comparison to other drugs for anxiety). 15068826
Thomsen M, Vitetta L, Schmidt M, Sali A. Fatal fulminant hepatic failure induced by a natural therapy containing kava. Med J Austr 2004; 180: 198-9. (Letter in response to Gow [2003] suggesting that a toxic factor or contaminant may have caused the hepatic injury rather than kava, the aqueous extracts of which show no hepatotoxicity in animal models; reply by authors states that this is possible but unlikely). 14960147
Anke J, Ramzan I. Pharmacokinetic and pharmacodynamic drug interactions with kava (Piper methysticum Forst. f.). J Ethnopharmacol 2004; 93: 153-60. (Several kavalactones found in kava extracts are potent inhibitors of P450 enzymes [CYP 1A2, 2C9, 2C19, 2D6, 3A4, 4A9/11] in vitro, suggesting that kava may have major herb-drug inactions). 15234747
Anke J, Ramzan I. Kava Hepatotoxicity: are we any closer to the truth? Planta Med 2004; 70: 193-6. (Discussion of the hepatotoxicity of kava containing herbal medications and possible mechanisms of liver injury). 15114493
Nerurkar PV, Dragull K, Tang C-S. In vitro toxicity of kava alkaloid, pipermethystine, in HepG2 cells compared to kavalactone. Toxicol Sci 2004; 79: 106-11. (In vitro studies identified pipermethystine, but not kavalactones as cytotoxic in HepG2 [hepatoma] cell lines). 14737001
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, one specifically attributed to kava). 15390328
Gurley JB, Gardner SF, Hubbard MA, Williams DK, Gentry WB, Han IA, Shah A. In vivo effects of goldenseal, kava kava, black cohosh, and valerian on human cytochrome P450 1A2, 2D6, 2E1, and 3A4/5 phenotypes. Clin Pharmacol Ther 2005; 77: 415-26. (In human volunteer studies, kava showed moderate inhibition of CYP 2E1 activity [40%] but no effect on CYP 1A2, 2D6 or 3A4, despite evidence in vitro that kava inhibits these isoenzymes; discussion raises issue of whether the dose of kava was high enough to show an effect). 15900287
Ulbricht C, Basch E, Boon H, Ernst E, Hammerness P, Sollars D, Tsourounis C, et al. Safety review of kava (Piper methysticum) by the Natural Standard Research Collaboration. Expert Opin Drug Saf 2005; 4: 779-4. (Systematic review of the safety of kava with a history of regulatory actions by country). 16011454
Weiss J, Sauer A, Frank A, Unger M. Extracts and kavalactones of Piper methysticum G. Forst (kava-kava) inhibit P-glycoprotein in vitro. Drug Metab Dispos 2005; 33: 1580-3. (Analysis of effects of kava extracts and purified components on the efflux transporter P-glycoprotein in an over expressing cell line found moderate to potent inhibitory activity of the extract and the kavalactones). 16051732
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports of drug induced liver injury to a Spanish network found 570 cases, herbal medications accounted for 9 cases). 16083708
Jhoo JW, Freeman JP, Heinze TM, Moody JD, Schnackenberg LK, Beger RD, Dragull K, et al. In vitro cytotoxicity of nonpolar constituents from different parts of kava plant(Piper methysticum). J Agric Food Chem 2006; 54: 3157-62. (Analysis of in vitro cytotoxicity of extracts of various parts of the kava plant, higher degrees of toxicity were found with organic solvent extracts and “flavokavain B” was identified as a cytotoxic component). 16608246
Clough AR, Currie BJ, Yunupingu MW, Conigrave KM. Action is required to reduce kava supply in Arnhem Land . . . again! Med J Aust 2006; 184: 91-2. (Letter documenting the rise in abuse of kava among Aboriginal people in Australia and call for further regulatory actions). 16411879
Musch E, Chrissafidou A, Malek M. Acute hepatitis due to kava kava and St John’s Wort: an immune-mediated mechanism? Dtsch Med Wochenschr 2006; 131: 1214-7. (48 year old woman developed jaundice 10 weeks after starting a kavain containing product [Neuronika] [bilirubin 1.6 rising to 20 mg/dL, ALT 412-752 U/L, Alk P 176-311 U/L], resolving in 3 months on prednisolone and azathioprine; authors argue for an immune mediated injury). 16721710
Loew D. [Acute hepatitis due to kava-kava and St John’s Wort: an immune-mediated mechanism]. Dtsch Med Wochenschr 2006; 131: 1780. German. (Letter in response to Musch [2006] questioning the interpretation of the injury as due to kava versus kavain, a synthetic product). 16915553
Teschke R. [Acute hepatitis due to kava-kava and St John's Wort: an immune-mediated mechanism?]. Dtsch Med Wochenschr 2006; 131: 1880-1. German. (Letter in response to Musch [2006] questioning the link of the liver injury with kava [vs kavain] and the theoretical role of kava-cytochrome P450 interactions in causing hepatotoxicity). 16915552
Siegers CP, Schmidt M. [Acute hepatitis due to kava-kava and St John's Wort: an immune-mediated mechanism?]. Dtsch Med Wochenschr 2006; 131: 1881-2. German. (Letter in response to Musch [2006] questioning the interpretation of the hepatotoxicity as immunoallergic and the use of prednisolone and azathioprine). 16915554
Droege H. [Acute hepatitis due to kava-kava and St John's Wort: an immune-mediated mechanism?]. Dtsch Med Wochenschr 2006; 131: 18823. German. (Letter in response to Musch [2006] pointing out that the product was kavain, a synthetic product, rather than kava-kava). 16915556
Ernst E. A re-evaluation of kava(Piper methysticum). Br J Clin Pharmacol 2007; 64: 415-7. (Commentary on hepatotoxicity of kava which was banned in Germany in 2002 and UK in 2003 with 100 cases of liver injury attributed to kava worldwide). 17555466
Teschke R, Schwarzenboeck A, Hennermann KH. Kava hepatotoxicity: a clinical survey and critical analysis of 26 suspected cases. Eur J Gastroenterol Hepatol 2008; 20: 1182-93. (Detailed analysis of 26 German and Swiss cases of suspected kava hepatotoxicity applying RUCAM found that only 3 cases could be considered probable and 6 cases possible, and that many of the patients had taken higher than recommended doses for longer than recommended periods, so that only 1 case could be considered probable and 2 possible who had taken kava in the recommended regimen; many cases had inadequate documentation). 18989142
Teschke R, Schwarzenboeck A, Akinci A. Kava hepatotoxicity: a European view. N Z Med J 2008; 121: 90-8. (Review of kava hepatotoxicity pointing out that most reported cases were poorly documented, involved use of higher than recommended doses for longer than recommended times and may have been due to poor extraction techniques, contamination or co-medications; concluded that kava induced liver injury may be real, but is rare). 18841189
Pittler MH, Ernst E. Kava extract for treating anxiety. Cochrane Database Syst Rev 2008; (1): CD003383. (In a systematic review and meta analysis, kava was found to effective in treatment of anxiety although the effect was small; kava was safe in the short term [1-24 weeks] and in monitoring studies including 7078 patients no evidence of hepatotoxicity was found). 12535473
Lude S, Torok M, Dieterle S, Jaggi R, Buter KB, Krahenbuhl S. Hepatocellular toxicity of kava leaf and root extracts. Phytomedicine 2008; 15: 120-31. (Three different kava extracts [methanolic and acetonic root and methanolic leaf extract] appeared toxic to mitochondria, leading to inhibition of the respiratory chain, increased reactive oxidant species production, and a decrease in the mitochondrial membrane potential culminating in apoptosis). 18055189
Fu PP, Xia Q, Guo L, Yu H, Chan P-C. Toxicity of kava kava. J Environmental Science and Health Part C 2008; 26: 89-112. (Review of issue of hepatotoxicity and of mechanisms leading to hepatotoxicity, including summary of animal studies, short term cytotoxicity tests, issues of herb-drug interactions, and formation of activated metabolites). 18322868
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, but kava was not specifically mentioned). 18955056
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by "natural remedies": an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, 1 due to kava kava; 34 year old woman developed ALT elevations [18 times ULN] 5 months after starting kava; resolving slowly over 14 months after stopping). 19159172
Chitturi S, Farrell GC. Hepatotoxic slimming aids and other herbal hepatotoxins. J Gastroenterol Hepatol 2008; 23: 366-73. (General review of herbal hepatotoxicity including kava). 18318821
Teschke R, Genthner A, Wolff A. Kava hepatotoxicity: comparison of aqueous, ethanolic, acetonic kava extracts and kava-herbs mixtures. J Ethnopharmacol 2009; 123: 378-84. (Review of literature on kava hepatotoxicity applying RUCAM scoring for causality to 5 published cases attributed to aqueous and 9 to ethanol-extracted kava, suggesting that liver injury occurs with both). 19501269
Teschke R, Wolff A. Kava hepatotoxicity: regulatory data selection and causality assessment. Digest Liver Dis 2009; 41: 891-901. (Analysis of 20 cases of suspected kava hepatotoxicity reported to German regulatory agency, using RUCAM to assess causality, found low level of evidence largely because of lack of information on clinical course [dechallenge] and exclusion of other causes, and use of other potentially hepatotoxic medications). 19477698
Christl SU, Seifert A, Seeler D. Toxic hepatitis after consumption of traditional kava preparation. J Travel Med 2009; 16: 55-6. (42 year old man developed jaundice 4 weeks after heavy kava drinking on a trip to Samoa [bilirubin 9.3 rising to 31 mg/dL, ALT 2841 U/L, Alk P 285 U/L], resolving in 5 weeks). 19192130
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Review of the problems of causality assessment in herbal and dietary supplement [HDS] associated liver disease, including the variable clinical presentations, the complexity and lack of information on their components, absence of controlled trials demonstrating safety and efficacy, the possibility of contamination or incorrect labeling and frequent underreporting of herbal use by patients. Regulation of HDS is under DSHEA, which requires manufacturers to determine safety and prohibits claims of efficacy in treating specific diseases. The US Pharmacopeia sets standards for food and drugs and includes HDS; HDS induced liver injury is a growing problem and currently accounts for at least 10% of cases of acute liver injury due to medications). 19826971
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry; no mention of kava). 19650152
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, but none were attributed to kava). 20949552
Teschke R. Kava hepatotoxicity: pathogenetic aspects and prospective considerations. Liver Int 2010; 30: 1270-9. (Review of the hepatotoxicity of kava). 20630022
Teschke R. Kava hepatotoxicity—a clinical review. Ann Hepatol 2010; 9: 251-65. (Review of the clinical features of kava hepatotoxicity with summaries of reported and published cases and discussion of difficulty in assigning causality to many). 20720265
Teschke R, Schulze J. Risk of kava hepatotoxicity and the FDA consumer advisory. JAMA 2010; 304: 2174-5. (Review of the evidence for and against the hepatotoxicity of kava: "Kava products of poor quality, non-adherence to usage recommendations or a combination of both appear to be the major causative factors"). 21081732
Teschke R, Schulze J. Risk of kava hepatotoxicity and the FDA consumer advisory. JAMA 2010; 304: 2174-5. (Editorial on status of efforts to insure safety of kava, focusing on water extraction of kava roots only and licensing of specific growers; kava remains available in the United States). 21081732
Teschke R, Sarris J, Lebot V. Kava hepatotoxicity solution: A six-point plan for new kava standardization. Phytomedicine 2011; 18: 96-103. (Summary of approaches to insure the safety of kava, including licensing cultivars, use of peeled and dry roots only, aqueous extraction, limitations on dose and quality of kavalactones, further research and quality control). 21112196
Teschke R, Wolff A. Regulatory causality evaluation methods applied in kava hepatotoxicity: are they appropriate? Regul Toxicol Pharmacol 2011; 59: 1-7. (Commentary arguing that banning of kava was based upon faulty analysis of reported cases of hepatotoxicity and need for better and more objective causality assessment tools). 20854865
Stacy S. Relaxation drinks and their use in adolescents. J Child Adolesc Psychopharmacol 2011; 21: 605-10. (Review of relaxation drinks which now include more than 300 bottled beverages available in the US, some of which include kava as an anxiolytic and sleeping aid with names such as Bula and Malava). 22136095
Stickel F, Kessebohm K, Weimann R, Seitz HK. Review of liver injury associated with dietary supplements. Liver Int 2011; 31: 595-605. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, Noni juice, Chinese herbs, vitamin A and anabolic steroids; kava not discussed). 21457433
Baker JD. Tradition and toxicity: evidential cultures in the kava safety debate. Soc Stud Sci 2011; 41: 361-84. (Sociological analysis of the controversy surrounding the safety of kava stressing the cultural, social, and professional ["context-specific"] bases for differing interterpretations of the same data). 21879526
Teschke R, Lebot V. Proposal for a kava quality standardization code. Food Chem Toxicol 2011; 49: 2503-16. (Detailed proposals for standardization of the cultivation, harvesting, processing and manufacture of kava so as to insure high quality and lack of adulteration of kava products). 21756963
Olsen LR, Grillo MP, Skonberg C. Constituents in kava extracts potentially involved in hepatotoxicity: a review. Chem Res Toxicol 2011; 24: 992-1002. (Review of the phytochemical composition of kava preparations and the potential hepatoxicity of the individual components). 21506562
Teschke R, Qiu SX, Xuan TD, Lebot V. Kava and Kava Hepatotoxicity: Requirements for Novel Experimental, Ethnobotanical and Clinical Studies Based on a Review of the Evidence. Phytother Res 2011 Mar 28. [Epub ahead of print] (Review of kava hepatotoxicity and the phytochemistry of kava, suggesting that aflatoxin contamination may be the cause of the rare instances of liver injury). 21442674
Teschke R, Qiu SX, Lebot V. Herbal hepatotoxicity by kava: update on pipermethystine, flavokavain B, and mould hepatotoxins as primarily assumed culprits. Dig Liver Dis 2011; 43: 676-81. (Review of evidence that pipermethystine or flavokavain B might be hepatotoxic and contamination with aflatoxins might be the cause of liver injury attributed to kava ingestion). 21377431
Teschke R, Sarris J, Glass X, Schulze J. Kava, the anxiolytic herb: back to basics to prevent liver injury? Br J Clin Pharmacol 2011; 71: 445-8. (Review of the history of the discovery of kava and its introduction into Western medicine followed by reports of hepatotoxicity and possible explanations, concluding that for safety and optimal quality of kava products it is necessary "to go back to basics, back to using water extracts of peeled noble kava rhizomes and roots"). 21284704
Rychetnik L, Madronio CM. The health and social effects of drinking water-based infusions of kava: a review of the evidence. Drug Alcohol Rev 2011; 30: 74-83. (Systematic review of the literature on safety of drinking kava found good evidence for side effects of skin rash, nausea, decreased appetite and weight loss, but no confirmed association with liver toxicity or permanent liver damage). 21219501
Sarris J, LaPorte E, Schweitzer I. Kava: a comprehensive review of efficacy, safety, and psychopharmacology. Aust N Z J Psychiatry 2011; 45: 27-35. (Review of the psychopharmacology, safety and efficacy of kava as an anxiolytic). 21073405
Teschke R, Fuchs J, Bahre R, Genthner A, Wolff A. Kava hepatotoxicity: comparative study of two structured quantitative methods for causality assessment. J Clin Pharm Ther 2010; 35: 545-63. (Analysis of 26 cases of suspected kava hepatotoxicity reported to regulatory agencies from Switzerland and Germany using the M&V and RUCAM causality assessment tools found most cases to be scored as "excluded" [16 and 15] or "unlikely" [7 and 2] by the two methods). 20831679
Sarris J, Teschke R, Stough C, Scholey A, Schweitzer I. Re-introduction of kava (Piper methysticum) to the EU: is there a way forward? Planta Med 2011; 77: 107-10. (Description of plans to evaluate the safety and efficacy of kava [Kalm project] in controlled trials with careful assessment of adverse events and mechanism of action using a well characterized kava product). 20814850
Teschke R, Sarris J, Schweitzer I. Kava hepatotoxicity in traditional and modern use: the presumed Pacific kava paradox hypothesis revisited. Br J Clin Pharmacol 2012; 73: 170-4. (Review and argument against the kava paradox, hepatotoxicity having occurred with traditional acqueous as well as with acetone or alcohol extracted preparations). 21801196
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, including 29 on kava). 22928722
Rowe A, Ramzan I. Are mould hepatotoxins responsible for kava hepatotoxicity? Phytother Res 2012; 26: 1768-70. (Letter arguing that the levels of alflatoxins reported to be found in kava preparations were not toxicologically significant and the most likely cause of kava hepatotoxicity are its natural constituents). 22319018
Sarris J, Stough C, Teschke R, Wahid Z, Bousman C, Murray G, Savage K, et al. Kava for the treatment of generalized anxiety disorder RCT: analysis of adverse reactions, liver function, addiction, and sexual effects. Phytother Res 2013; 27: 1723-8. (Controlled trial of kava [60-120 mg kavalactones twice daily] vs placebo for 6 weeks in 58 patients with generalized anxiety disorder found no change in ALT levels or other liver tests in either group). 23348842
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of literature on HDS associated liver injury discusses the controversy over the potential hepatotoxicity of kava). 23121117
Toohey TP, Lu BY, Wada C. Toxic effects of psychotropics related to possible p450 enzyme inhibition by kava: report of 2 cases. Prim Care Companion CNS Disord 2013; 15 (5). pii. (Two women, ages 60 and 80 years old, on long term psychotropic agents [haloperidol, lorazepam, ropinirole] developed acute psychosis after starting or increasing daily kava use, suggesting herb-drug interactions). 24511438
Teschke R, Schulze J, Schwarzenboeck A, Eickhoff A, Frenzel C. Herbal hepatotoxicity: suspected cases assessed for alternative causes. Eur J Gastroenterol Hepatol 2013; 25: 1093-8. (Review of literature of case series of suspected HDS related liver injury found evidence of other explanations in 19 of 23 publications, involving 278 of 573 patients [49%] and including 50-58% of kava attributed cases; these other diagnoses weakened the causality assessment in most instances). 23510966
Teschke R, Sarris J, Lebot V. Contaminant hepatotoxins as culprits for kava hepatotoxicity--fact or fiction? Phytother Res 2013; 27: 472-4. (Commentary and proposal of possible solutions to kava hepatotoxicity based upon standardization of cultivation, harvest, avoidance of contamination, use of aqueous extracts and limitation of dose and duration of therapy). 22585547
Teschke R, Eickhoff A, Wolff A, Frenzel C, Schulze J. Herbal hepatotoxicity and WHO global introspection method. Ann Hepatol 2013; 12: 11-21. (Commentary on the WHO global introspection method because of its specificity for liver injury and attention to alternative explanations, such as hepatitis and other viral infections). 23293189
Sarris J, Stough C, Bousman CA, Wahid ZT, Murray G, Teschke R, Savage KM, et al. Kava in the treatment of generalized anxiety disorder: a double-blind, randomized, placebo-controlled study. J Clin Psychopharmacol 2013; 33: 643-8. (Controlled trial of 6 weeks of kava vs placebo in 58 patients with general anxiety disorder, found that 24% of kava vs 17% of placebo recipients developed elevated liver tests, but none developed clinically apparent liver injury [same study as described in Sarris et al. Phytotherapy Research 2013]). 23635869
Rossi S, Navarro VJ. Herbs and liver injury: A clinical perspective. Clin Gastroenterol Hepatol 2014; 12: 1069-76. (Review of current status of liver injury due to HDS including discussion of challenges of establishing causality and difficulties in identifying the potentially hepatotoxic component; discusses controversy surrounding hepatotoxicity of kava). 23924877
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, none of which listed kava as a component). 23419359
Licata A, Macaluso FS, Craxì A. Herbal hepatotoxicity: a hidden epidemic. Intern Emerg Med 2013; 8: 13-22. (Review and commentary on herbal hepatotoxicity discusses kava). 22477279
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; mentions that kava containing products have been linked to cases of hepatitis, some of which were fatal or led to emergent liver transplantation). 24099027
Dağ MS, Aydınlı M, Oztürk ZA, Türkbeyler IH, Koruk I, Savaş MC, Koruk M, et al. Drug- and herb-induced liver injury: a case series from a single center. Turk J Gastroenterol 2014; 25: 41-5. (Between 2008 and 2012, 82 patients with drug or herbal supplement induced liver injury were seen at a single referral center in Turkey, 10 [12%] of which were due to HDS products, including 7 due to Teucrium polium [mountain germander] and 3 to green tea, but none to kava). 24918129
Teschke R, Genthner A, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: Analysis of cases with initially reported positive re-exposure tests. Dig Liver Dis 2014; 46: 264-9. (Reanalysis of 34 published cases of liver injury due to herbal medications in which there was a reported positive rechallenge, finding only 21 [62%] fulfilled the criteria of a positive rechallenge using RUCAM, the others having inconsistent [18%] or incomplete data [21%]; among 2 cases attributed to kava, 1 had a positive rechallenge and was considered highly probable while the other had an uninterpretable rechallenge yet was still considered probable). 24315480
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60:1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, kava was a component of products taken by two patients , but both were also exposed to other potentially hepatotoxic herbs). 25043597
Navarro VJ, Lucena MI. Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis 2014; 34: 172-93. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment, mentions that kava has been linked to cases of cholestatic and hepatocellular hepatitis some of which were fatal). 24879982
Korth C. Drug-induced hepatotoxicity of select herbal therapies. J Pharm Pract 2014; 27: 567-72. (Review of liver injury due to selected HDS discusses the literature implicating kava, green tea extract, germander, pyrrolizidine alkaloids and Herbalife products). 25546878
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology 2015; 148: 517-32. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver mentions that there have been more than 100 reports of clinically apparent liver injury from kava). 25500423
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea and only 2 cases had exposure to a kava containing product [Navarro et al Hepatology 2014]). 25754159
Stickel F, Shouval D. Hepatotoxicity of herbal and dietary supplements: an update. Arch Toxicol. 2015; 89: 851-65. (Extensive review of liver injury due to HDS mentions that kava has been implicated in more than 100 cases of clinically apparent liver injury including 9 instances of acute liver failure, 3 of which resulted in deaths). 25680499
Aghdassi AA, Kraft M, Domschke W, Lerch MM, Weiss FU. Genetic polymorphisms in the UDP-glucuronosyltransferase UGT1A7 gene in patients with acute liver failure after kava-kava consumption. Arch Toxicol 2015; 89: 2173-4. (Letter in response to Stickel [2015] suggesting that variants of UGT1A7*3 might explain the rare instances of kava related severe liver injury, the allele frequency being 37% in patients with acute liver failure attributed to kava, vs 16% to 36% of controls). 26298863
Stickel F. Response to Aghdassi et al., Letter to the editor "Genetic polymorphisms in the UDP-glucuronosyltransferase UGT1A7 gene in patients with acute liver failure after kava-kava consumption". Arch Toxicol 2015; 89: 2175-6. (Reply to the letter of Aghdassi [2015] arguing that the number of patients studied was few and that UGT1A7*3 is not expressed in the liver). 26475488
Kuchta K, Schmidt M, Nahrstedt A. German kava ban lifted by court: the alleged hepatotoxicity of kava (Piper methysticum) as a case of ill-defined herbal drug identity, lacking quality control, and misguided regulatory politics. Planta Med 2015; 81: 1647-53. (Commentary and review of the 2014 German court reversal of the 2002 regulatory ban of kava [BfArM 2002]). 26695707
Pantano F, Tittarelli R, Mannocchi G, Zaami S, Ricci S, Giorgetti R, Terranova D, et al. Hepatotoxicity induced by "the 3Ks": kava, kratom and khat. Int J Mol Sci 2016; 17: 580. (Review of the components and laboratory and clinical evidence for hepatotoxicity of three herbals: kava, kratom and khat). 27092496
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci 2016; 17. pii: E537. (Listing of published cases of liver injury from HDS products, but does not list those attributed to kava). 27070596
Avigan MI, Mozersky RP, Seeff LB. Scientific and regulatory perspectives in herbal and dietary supplement associated hepatotoxicity in the United States. Int J Mol Sci 2016; 17: 331. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/26950122) (Overview of the US regulations regarding herbal and dietary supplements and role of FDA, Department of Agriculture, Federal Trade Commission and Office of Dietary Supplements of the NIH in assessment of safety of HDS products including actions taken against Hydroxycut, Lipokinetix and OxyELITE Pro when reports of liver injury appeared in postmarketing phase).
Marcus DM. Dietary supplements: What's in a name? What's in the bottle? Drug Test Anal 2016; 8 (3-4): 410-2. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/27072845) (Commentary on regulation of HDS products concludes: "the marketing of botanical supplements is based on unfounded claims that they are safe and effective", and "there is no reason to take herbal medicines whose composition and benefits are unknown and whose risks are evident").
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements). 27818322
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists at least 10 reports of liver injury attributed to kava). 27402097
Wong LL, Lacar L, Roytman M, Orloff SL. Urgent liver transplantation for dietary supplements: an under-recognized problem. Transplant Proc 2017; 49: 322-5. (Among 2048 adult liver transplants recipients enrolled in the Scientific Registry of Transplant Recipients [SRTR] between 2003 and 2015, 625 were done for acute hepatic necrosis due to drug induced liver injury, half being due to acetaminophen and the 4th most frequent cause [n=21] being HDS products). 28219592
de Boer YS, Sherker AH. Herbal and dietary supplement-induced liver injury. Clin Liver Dis 2017; 21: 135-49. (Review of the frequency, clinical features, patterns of injury and outcomes of HDS hepatotoxicity with specific mention of anabolic steroids, black cohosh, germander, green tea, kava, pyrrolizidine alkaloids and proprietary multiingredient nutrition supplements [MINS]). 27842768
Vega M, Verma M, Beswick D, Bey S, Hossack J, Merriman N, Shah A, et al; Drug Induced Liver Injury Network (DILIN). The incidence of drug- and herbal and dietary supplement-induced liver injury: preliminary findings from gastroenterologist-based surveillance in the population of the State of Delaware. Drug Saf 2017; 40: 783-7. (A prospective, population based registry of cases of drug induced liver injury occurring in Delaware during 2014, identified 20 cases [2.7 per 100,000] overall, including 6 due to HDS products, all of which were proprietary multiingredient products, none specifically listing kava as a component). 28555362
Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. Liver injury from herbal and dietary supplements. Hepatology 2017; 65: 363-73. (Review of the problems of liver injury and HDS products, specifically discusses anabolic steroids, green tea extract and OxyELITE Pro, but does not mention kava). 27677775

## OTHER REFERENCE LINKS

1. Recent References on Kava Kava: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=kava+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Kava Kava: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=kava)